# Amitriptyline

## OVERVIEW

### Introduction

Amitriptyline is a tricyclic antidepressant that is widely used in the therapy of depression. Amitriptyline can cause mild and transient serum enzyme elevations and is rare cause of clinically apparent acute cholestatic liver injury.

### Background

Amitriptyline (am" i trip' ti leen) is a tricyclic antidepressant which is believed to act by inhibition of serotonin and norepinephrine reuptake within synaptic clefts in the central nervous system, thus increasing brain levels of these neurotransmitters. Amitriptyline is indicated for therapy of depression and was approved for this indication in the United States in 1961, and is still widely used, with more than 10 million prescriptions for amitriptyline being filled yearly. Amitriptyline is also used for anorexia and bulimia and for adjunctive treatment of neurogenic pain. Amitriptyline is available in generic forms and under the brand name of Elavil in 10, 25, 50, 75, 100 and 150 mg tablets. The typical recommended dose for depression in adults is 75 to 100 mg daily in divided doses, increasing gradually to a maximum of 300 mg daily. Amitriptyline can also be given as a single nighttime dose of 50 to 150 mg. Common side effects include dizziness, headache, drowsiness, restlessness, confusion, gastrointestinal upset, increased appetite, weight gain, blurred vision, dry mouth and urinary retention.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in 10% to 12% of patients on amitriptyline, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually mild, asymptomatic and transient, reversing even with continuation of medication. Rare instances of clinically apparent acute liver injury have been reported in patients on amitriptyline. The latency to onset is quite variable, ranging from 1 to 14 months of starting the medication. The reported pattern of serum enzyme elevations has varied from hepatocellular to cholestatic. An acute hepatitis-like syndrome with acute liver failure has been reported, as well as acute cholestatic hepatitis and prolonged jaundice compatible with vanishing bile duct syndrome. Signs or symptoms of hypersensitivity (rash, fever and eosinophilia) are frequent, but are usually mild and transient. Autoantibody formation is rare.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which amitriptyline causes serum aminotransferase elevation is not known. It undergoes extensive hepatic metabolism and a possible cause of liver injury is production of a toxic intermediate of metabolism. Many cases have features of hypersensitivity and more rapid recurrence with reexposure and it has been associated with a specific HLA haplotype (A11).

### Outcome and Management

The serum aminotransferase elevations that occur on amitriptyline therapy are usually self-limited and do not require dose modification or discontinuation of therapy. The acute liver injury caused by amitriptyline is typically self-limited, but progressive and fatal instances of acute hepatitis and prolonged cholestasis with vanishing bile duct syndrome have been reported. Rechallenge with amitriptyline usually causes a prompt recurrence of the liver injury which can be fatal and should be avoided. Cross reactivity of hepatic injury with other tricyclic antidepressants has been described, but is not invariable. Thus, switching from one to another tricyclic antidepressant after clinically apparent liver injury should be avoided or done with caution. Switching to other forms of antidepressants such as the selective serotonin reuptake inhibitors is likely to be safe.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, Tricyclics: Amoxapine, Clomipramine, Desipramine, Doxepin, Imipramine, Nortriptyline, Protriptyline, Trimipramine

## CASE REPORTS

### Case 1. Acute liver failure due to amitriptyline.

[Modified from: Danan G, Bernuau J, Moullot X, Degott C, Pessayre D. Amitriptyline-induced fulminant hepatitis. Digestion 1984; 30: 179-84. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/6500194)]

A 51 year old woman developed fever and arthralgias followed 2 days later by jaundice, approximately 14 months after starting amitriptyline (30 mg daily) and perphenazine (12 mg daily). She was icteric and febrile but without rash or pruritus. Serum bilirubin levels were elevated (Table) and ALT levels were 27 times the upper limit of the normal range. She tested negative for hepatitis B surface antigen and an ultrasound showed no evidence of biliary obstruction. The symptoms and jaundice resolved with stopping the medication and all tests were normal 2 months later. Soon thereafter, however, amitriptyline and perphenazine were restarted. Within 12 days, she redeveloped jaundice and fever that progressed to hepatic failure marked by confusion, asterixis and ascites. There was no eosinophilia or autoantibodies. A transjugular liver biopsy showed massive necrosis. Serum bilirubin levels peaked a week after stopping therapy and then improved. She again had a slow clinical recovery, and four months later all liver tests were normal.

#### Key Points

Medication: | Amitriptyline
Pattern: | Hepatocellular (R=22)
Severity: | 4+ (prolonged jaundice, liver failure)
Latency: | Initially 14 months, 12 days on rechallenge
Recovery: | Four months
Other medications: | Perphenazine, sulpiride

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Amitriptyline and perphenazine given for ~14 months
14 months | 0 | 920 | Normal | 4.4 | Fever and jaundice
| 1 week | 1080 | | 9.4
| 2 weeks | 560
| 4 weeks | 80 | | 2.9
| 8 weeks | 40 | | 1.2
Amitriptyline and perphenazine restarted for 12 days
12 days | 0 | 960 | | 6.4 | Asterixis and ascites
| 4 days | 1040 | | 14.6
| 1 week | 1360 | | 15.2
| 2 weeks | 840 | | 16.4
| 3 weeks | 200 | | 23.4 | Liver biopsy
| 4 weeks | 160 | | 16.4
| 5 weeks | 140 | | 8.8
| 6 weeks | 80 | | 5.8
| 4 months | Normal | Normal | Normal
Normal Values | | <42 | | <1.2

* Values estimated from Figure 2 and converted from x ULN to U/L and μmol/L to mg/dL.

#### Comment

The latency to onset was unusually long for tricyclic induced liver injury, but the rapid recurrence with rechallenge provided convincing evidence for a link between either amitriptyline or perphenazine and this acute hepatitis like reaction. Attribution of the injury to amitriptyline rather than perphenazine (a phenothiazine that has not been clearly linked to drug induced liver injury) rests largely on previous case reports and the hepatocellular pattern of injury, which is more typical of tricyclic than phenothiazine induced injury. The severity of the response to rechallenge argues against this practice particularly when dealing with hepatocellular injury.

### Case 2. Cholestatic hepatitis due to amitriptyline.

[Modified from: Anderson BN, Henrikson IR. Jaundice and eosinophilia associated with amitriptyline. J Clin Psychiatry 1978; 39: 730-1. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/690091)]

A 55 year old woman developed pruritus 4 weeks after starting amitriptyline therapy for depression. She stopped taking the medication, but then noticed the onset of jaundice several days later. She had no previous history of liver disease or exposures to hepatitis and drank no alcohol. Her only other medication was flurazepam. On examination, she was jaundiced but had no fever or rash. Total bilirubin was 8.0 mg/dL and serum alkaline phosphatase and AST levels were elevated (Table). These tests had been normal shortly before she started taking amitripyline. Tests for hepatitis B and autoantibodies were negative and a liver scan was normal. She had eosinophilia which had been documented on routine blood counts taken 2 and 3 weeks after starting amitriptyline. Her jaundice and abnormal liver tests resolved over the following six weeks and her depression was managed using electrotherapy.

#### Key Points

Medication: | Amitriptyline
Pattern: | Cholestatic (R=0.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 weeks
Recovery: | 6 weeks
Other medications: | Flurazepam

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 10 | 35 | 0.5 | Eosinophils 2%
2 weeks | | | | | Eosinophils 33%
3 weeks | | | | | Eosinophils 16%
Amitriptyline stopped because of pruritus
5 weeks | 0 | 44 | 170 | 8.0 | Eosinophils 10%
6 weeks | 1 week | 110 | 150 | 8.1 | Eosinophils 7%
6.5 weeks | 1.5 weeks | 58 | 140 | 6.0
7 weeks | 2 weeks | | | 5.0
11 weeks | 6 weeks | 53 | | 1.3
7 months | 6 months | 45 | | 1.0
Normal Value | | <40 | <85 | <1.2

#### Comment

The latency of 3 to 4 weeks and cholestatic features are typical of tricyclic induced liver injury. The detection of marked eosinophilia during the first few weeks of therapy suggests a hypersensitivity reaction, but there was no rash or fever. Resolution of cholestatic hepatitis is usually slower than that of acute hepatocellular injury of similar severity.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amitriptyline – Elavil®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=amitriptyline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Amitriptyline | 50-48-6 | C20-H23-N | Image of Amitriptyline Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 March 2016

Zimmerman HJ. Tricyclic antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 495-8. (Expert review of hepatotoxicity published in 1999; hepatic injury caused by tricyclic antidepressants is less frequent and less consistent than with monamine oxidase inhibitors).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of tricylic antidepressant hepatotoxicity; serum enzyme elevations arise in 10% of amitriptyline treated patients; the prevalence of clinical hepatitis is low; the pattern of liver enzyme elevations varies; latency ranges from 1 week to 10 months; immunoallergic features are common).
O'Donnell JM, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics).
Holmberg MB, Jansson B. A study of blood count and serum transaminases in prolonged treatment with amitriptyline. J New Drugs 1962; 2: 361-5. (Prospective monitoring in 100 patients on amitriptyline for up to one year; 38% had mild eosinophilia [all <10%]; ALT elevations occurred in 10%, but highest value was 77 U/L, which was less than twice normal). 1396401
Klerman GL, Cole JO. Clinical pharmacology of imipramine and related antidepressant compounds. Pharmacol Rev 1965; 17: 101-41. (Extensive review of structure, pharmacology, clinical effects, mechanisms of action, drug interactions, and side effects of tricyclic antidepressants; jaundice occurs in 0.5 to 1% of treated persons and usually resolves rapidly with stopping). 14294030
Cunningham ML. Acute hepatic necrosis following treatment with amitriptyline and diazepam. Br J Psychiatry 1965; 111: 1107-9. (54 year old woman developed drowsiness and confusion followed by jaundice 6 months after starting amitriptyline and diazepam [bilirubin 5.2 mg/dL, ALT 220 U/L, Alk P 95 U/L], with progressive coma and death 1 week later, autopsy showing massive necrosis). 5841222
Biagi RW, Bapat BN. Intrahepatic obstructive jaundice from amitriptyline. Br J Psychiatry 1967; 113: 1113-4. (Woman of unstated age developed jaundice and pruritus 7 months after starting amitriptyline [bilirubin 3.8 rising to 12.0 mg/dL, ALT 14 U/L, Alk P 2 times ULN], resolving within 2 months of stopping). 6057380
Kramp JL. Glutamic pyruvic acid transaminases during treatment with amitriptyline and imipramine. Acta Psychiatr Scand 1967; 43: 1-7. (ALT was elevated in 4 of 149 patients treated with amitriptyline or imipramine, but peak value was only 100 U/L). 6059707
Morgan DH. Jaundice associated with amitriptyline. Br J Psychiatry 1969; 115: 105-6. (2 men and 1 woman, ages 40, 45 and 24 years, developed jaundice 14, 3 and 10 weeks after starting amitriptyline [bilirubin 42, 1.6 and 13.2 mg/dL, ALT 96, 40 and 800 U/L, Alk P 1-3 times ULN], 2 recovered and 1 died; one had recurrence 8 days after restarting). 5781951
Clarke AE, Maritz VM, Denborough MA. Phenothiazines and jaundice. Aust N Z J Med 1972; 2: 376-82. (Chlorpromazine and amitriptyline cause precipitation of proteins when added to human bile in vitro and hepatotoxicity of these agents may relate to this characteristic). 4144624
Yon J, Anuras S. Hepatitis caused by amitriptyline therapy. JAMA 1975; 232: 833-4. (23 year old man developed liver test abnormalities 8 months after starting amitriptyline [bilirubin normal, ALT 80 U/L, Alk P 270 U/L], resolving rapidly upon stopping and recurring 8 days after restarting [ALT 240 U/L, Alk P 270 U/L]). 1173187
Fiori MG. Tricyclic antidepressants: a review of their toxicology. Curr Dev Psychopharmacol 1977; 4: 71-110. (Review of cardiac, hepatic, neurological, fetal and psychotoxicity of tricyclic antidepressants; most cases of hepatotoxicity have been attributed to hypersensitivity, but tricyclics are taken up and extensively metabolized by hepatocytes). 340145
Anderson BN, Henrikson IR. Jaundice and eosinophilia associated with amitriptyline. J Clin Psychiatry 1978; 39: 730-1. (55 year old woman developed pruritic rash and jaundice 3 weeks after starting amitriptyline [bilirubin 8.0 mg/dL, ALT 77 U/L, Alk P 170, 10% eosinophilia], resolving rapidly upon stopping: Case 2). 690091
Giller EL Jr, Bialos DS, Docherty JP, Jatlow P, Harkness L. Chronic amitriptyline toxicity. Am J Psychiatry 1979; 136: 458-9. (54 year old woman with cirrhosis had high amitriptyline levels and recurrent anticholinergic symptoms when treated with it, perhaps due to impaired hepatic metabolism). 426118
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (Among 572 cases of drug induced liver disease seen between 1968-78 in Denmark, psychotropic agents accounted for 93 cases, 54 of which were due to chlorpromazine; tricyclics not specifically mentioned). 6982502
Danan G, Bernuau J, Moullot X, Degott C, Pessayre D. Amitriptyline-induced fulminant hepatitis. Digestion 1984; 30: 179-84. (51 year old woman developed jaundice and fever 2 months after starting amitriptyline [peak bilirubin 9.4 mg/dL, ALT 27 times ULN, Alk P normal], resolving within 2 months of stopping and recurring 14 days after restarting with acute liver failure and peak bilirubin 23.8 mg/dL, with slow but complete recovery over next 4 months: Case 1). 6500194
Larrey D, Rueff B, Pessayre D, Algard M, Geneve J, Benhamou JP. Cross hepatotoxicity between tricyclic antidepressants. Gut 1986; 87-90. (39 year old woman developed abdominal pain 2 weeks after starting amineptine [a tricyclic antidepressant] with fever and eosinophilia [bilirubin 1.2 mg/dL, ALT 1360 U/L, Alk P 1.5 times ULN], resolving rapidly upon stopping and recurring 7 days after starting clomipramine [another tricyclic] [ALT 1050 U/L, Alk P 1.5 times ULN], again resolving rapidly upon stopping). 3721296
Geneve J, Larrey D, Pessayre D, Benhamou JP. Structure tricyclique des medicaments et hepatotoxicite. Gastroenterol Clin Biol 1987; 11: 242-9. (Review of structural similarity and hepatotoxicity of tricyclic antidepressants focusing on amineptine, imipramine and amitriptyline). 2884161
Larrey D, Amouyal G, Pessayre D, Degott C, Danne O, Machayekhi JP, Feldmann G, et al. Amitriptyline-induced prolonged cholestasis. Gastroenterology 1988; 94: 200-3. (37 year old man developed jaundice 5 weeks after starting amitriptyline [bilirubin 5.9 mg/dL, ALT 6.5 times ULN, Alk P 1.3 times ULN]; the drug was continued and bilirubin peaked at 23.4 mg/dL with 8% eosinophils and subsequent prolonged jaundice and pruritus [19-20 months] and ductopenia on liver biopsy). 3335290
Brems JJ, Merenda GO, Hayek ME, Kane RE, Flynn MF, Kaminski DL. Orthotopic liver transplantation resulting in amitriptyline toxicity in the recipient. Transplantation 1989; 48: 159-61. (Transplantation of liver from a donor with fatal amitriptyline overdose, followed by acute hepatic failure in the recipient who recovered with retransplantation). 2665225
Pirmohamed MKL, Kittringham NR, Parkl BK. Idiosyncratic reactions to antidepressants : a review of the possible mechanism and predisposing factors. Pharm Ther 1992; 53: 105-25. (Review of idiosyncratic reactions to antidepressants; possible mechanism of injury being production of a chemically reactive metabolite that is either directly toxic or induces a hypersensitivity reaction). 1641399
Berson A, Fréneaux E, Larrey D, Lepage V, Douay C, Mallet C. Possible role of HLA in hepatotoxicity. An exploratory study. J Hepatol 1994; 20: 336-42. (Human leukocyte antigen [HLA] haplotypes done on 71 patients with drug induced liver disease, 12 due to tricyclics including 7 amineptine, 3 amitriptyline and 2 clomipramine; 6 [50%] had HLA A11 including 2 of the 3 amitriptyline cases; 12% in controls). 8014443
Remy AL, Larrey D, Pageaux GP, Desprez D, Ramos J, Michel H. Cross hepatotoxicity between tricyclic antidepressants and phenothiazines. Eur J Gastroenterol 1995; 7: 373-6. (65 year old woman developed fatigue and serum enzyme elevations [ALT ~1300 U/L; Alk P ~380 U/L] 1 month after starting trimipramine; 3 years later she developed nausea and ALT elevations 10 days after starting desipramine [ALT ~250 U/L], and 2 years later developed abdominal pain and fever and enzyme elevations [ALT ~1100 U/L, Alk P ~510 U/L] 8 days after starting cyamemazine; each time with rapid recovery and no jaundice). 7600146
Grohmann R, Rüther E, Engel RR, Hippius H. Assessment of adverse drug reactions in psychiatric inpatients with the AMSP drug safety program: methods and first results for tricyclic antidepressants and SSRIs. Pharmacopsychiatry 1999; 32: 21-8. (Analysis of reporting of adverse events among inpatients in 29 German hospitals between 1993 to 1997; among 48,564 patients, severe adverse events were reported in 896 [1.8%], both total and hepatic events were more common with tricyclics than SSRIs). 10071179
Randeva HS, Bangar V, Sailesh S, Hillhouse EW. Fatal cholestatic jaundice associated with amitriptyline. Int J Clin Pract 2000; 54: 405-6. (75 year old woman developed fatigue and jaundice 4 months after starting amitriptyline [bilirubin 3.2 mg/dL, ALT 42 U/L, Alk P 400 U/L], progressing to fatal hepatic failure despite stopping drug promptly). 11092117
Milionis HJ, Skopelitou A, Elisaf MS. Hypersensitivity syndrome caused by amitriptyline administration. Postgrad Med J 2000; 76: 361-3. (24 year old woman developed rash and fever 3 weeks after starting amitriptyline with erythroderma and lymphadenopathy [bilirubin normal, ALT 103 U/L, Alk P normal, 25% eosinophilia], resolving on corticosteroids within 1 month of stopping amitriptyline). 10824052
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI. Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry 2002; 63: 135-7. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000). 11874214
Milkiewicz P, Chilton AP, Hubscher SG, Elias E. Antidepressant induced cholestasis: hepatocellular redistribution of multidrug resistant protein (MRP2). Gut 2003; 52: 300-3. (Two cases of cholestasis; 30 year old woman with jaundice 8 weeks after starting citalopram [bilirubin 4.4 mg/dL, AST 33 U/L, Alk P 637 U/L], resolving within 2 months of stopping; 63 year old man developed jaundice 3 months after starting dothiepin [a tricyclic antidepressant] [bilirubin 9.4 mg/dL, AST 40 U/L, Alk P 600 U/L], resolving on corticosteroids within 3 months of stopping and later tolerating fluoxetine for 12 months, but redeveloping jaundice after 2 months of paroxetine [bilirubin 15.2 mg/dL, AST 36 U/L, Alk P 544 U/L], resolving slowly by 6 months after stopping). 12524417
Lucena M, Carvajal A, Andrade R, Velasco A. Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf 2003; 2: 249-62. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; tricyclics less likely to cause injury than MAO inhibitors; predominantly cholestatic patterns with onset in first 2-3 weeks; occasional reports of prolonged cholestasis). 12904104
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry 2004; 37 Suppl 1: S39-45. (53,042 patients treated with antidepressants in 35 psychiatric hospitals in Germany from 1993-2000 were monitored for adverse drug reactions; increased liver enzymes reported in 16% on tricyclics, 5.5% on SSRIs and 12% of monamine oxidase inhibitors). 15052513
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were due to amitriptyline with a relative risk of 14.2: estimated frequency of 6 per 100,000 person-year exposures). 17539979
DeSanty KP, Amabile CM. Antidepressant-induced liver injury. Ann Pharmacother 2007; 41: 1201-11. (Review of drug induced liver injury and summary analysis of reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents). 17609231
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, only 1 case was attributed to amitriptyline, no other tricyclic mentioned). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to amitriptyline). 20949552
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to anticonvulsants and CNS agents; one case was attributed to amitriptyline). 21788760
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to amitriptyline or other tricyclic antidepressant). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, at least one case of which was attributed to amitriptyline). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants, but only one to a tricyclic - imipramine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Amitriptyline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(amitriptyline)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Amitriptyline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=amitriptyline)